# Antiasthmatic Agents

## OVERVIEW

Asthma is a respiratory illness marked by recurrent episodes of airway obstruction, an exaggerated bronchoconstriction response to environmental stimuli, and varying degrees of airway inflammation. Asthma is common, affecting at least 5% of the adult population and often arising in childhood. Asthma can also be severe and is a major cause of morbidity and even mortality in children and young adults.

The therapy of asthma consists of various combinations of inhaled and oral medications, with parenteral agents used during severe attacks. The major classes of agents used for asthma include beta adrenergic agonists, xanthine derivatives, anticholinergic agents, corticosteroids, antileukotrienes, monoclonal antibodies, and miscellaneous agents.

Hepatotoxicity is rare with most antiasthma medications but can occur, particularly with the antileukotrienes. Only oral and parenteral antiasthma agents have been linked to drug induced liver disease. The various inhaled agents have not been definitely linked to liver injury and are not discussed in any detail in this website.

Beta adrenergic bronchodilators act by activation of beta-2 adrenergic receptors on smooth muscle of bronchial tissue, causing relaxation and relief of the bronchoconstriction typical of asthma. Two forms of beta agonists are used in therapy of asthma: short acting agents such as albuterol (salbutamol), bitolterol, metaproterenol and terbutaline; and, the long acting beta agonists such as salmeterol and formoterol. None of these agents has been associated with hepatotoxicity when given orally or by inhalation.

Xanthine derivatives include theophylline which is available in oral forms and was formerly in common use, but has been declining in use with the availability of other more effective and better tolerated agents. Theophylline has not been associated with hepatotoxicity in usual oral doses.

Anticholinergic agents are often used in inhalers to treat symptoms of asthma and chronic obstructive pulmonary disease. They act by blocking endogenous acetylcholine from engaging muscarinic receptors which results in inhibition of bronchial smooth muscle constriction and reduction in mucus secretion. Use of anticholinergic agents in asthma has not been associated with hepatotoxicity.

Corticosteroids are effective in reducing symptoms in asthma and are frequently included in inhalers in combination with beta adrenergic bronchodilators. Corticosteroids act by modulating gene expression, suppressing synthesis of pro-inflammatory and increasing synthesis of antiinflammatory signaling molecules and cytokines. Administration of corticosteroids by inhalation rather than orally avoids many of the short- and long term adverse effects of corticosteroids. There is no evidence that corticosteroid inhalers cause live injury.

Antileukotrienes include the leukotriene receptor antagonists montelukast and zafirlukast, and the lipoxygenase inhibitor zileuton. These agents act by inhibiting the actions or synthesis of the leukotrienes which are potent inflammatory signals that are important mediators of inflammation and injury in asthma. These agents are used for the prevention of asthmatic attacks rather than their acute treatment. All three agents have been associated with rare instances of idiosyncratic, clinically apparent liver injury.

A relatively new approach to therapy of asthma is the use of monoclonal antibodies to inflammatory mediators such as IgE or eosinophils. Omalizumab (Xolair, 2003) is a recombinant humanized monoclonal antibody to IgE that acts by preventing the binding of IgE to mast cells and thus blocking the release of inflammatory mediators of the allergic response. Mepolizumab (Nucala, 2015), reslizumab (Cinqair, 2016) and benralizumab (Fasenra, 2017) are humanized monoclonal antibodies to IL-5 and its receptor, a cytokine that promotes the production and maturation of eosinophils. More recently approved for both eosinophilic asthma and atopic dermatitis is dupilumab (Dupixent, 2019), a human monoclonal antibody to the IL-4 receptor alpha subunit, which blocks the activity of IL-4 and IL-13 which are cytokines that drive inflammation in asthma and atopic dermatitis. The monoclonal antibodies for asthma require parenteral administration and are typically given as an infusion or subcutaneous injection every 2, 4 or 8 weeks. They are generally reserved for cases of severe, persistent asthma with an eosinophilic phenotype that have not responded adequately to conventional therapies. The monoclonal antibodies used for asthma rarely cause serum enzyme elevations and have not been implicated in cases of clinically apparent liver injury.

Miscellaneous agents include cromolyn sodium, which is used by inhaler and has not been definitely linked to cases of clinically apparent liver injury.

The following links are to individual drug records.

- Beta-2 Adrenergic Agonistso Albuterol, Bitolterol, Formoterol, Metaproterenol, Pirbuterol, Salbutamol, Salmeterol, Terbutaline
- Leukotriene Receptor Antagonists
  - Montelukast, Zafirlukast
- Monoclonal Antibodies
  - Benralizumab, Dupilumab, Mepolizumab, Omalizumab, Reslizumab, Tezepelumab
- Xanthine Derivatives
  - Theophylline
- Zileuton

## ANNOTATED BIBLIOGRAPHY

References updated: 28 December 2020

Barnes PJ. Pulmonary pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 727-49. (Textbook of pharmacology and therapeutics).
(2003). Omalizumab (Xolair): an anti-IgE antibody for asthma. Med Lett Drugs Ther. (Concise review of the safety and efficacy of omalizumab in asthma, states that common adverse effects include injection site reactions, rash, diarrhea, nausea, vomiting and epistaxis, and that there have been rare episodes of anaphylaxis [0.09%]; no mention of liver injury or ALT elevations).
Crompton G. (2006). A brief history of inhaled asthma therapy over the last fifty years. Prim Care Respir J. (The first modern, pressurized, metered dose inhaler for use in asthma was introduced in 1956; initially using short acting beta-agonists [isoprenaline, fenoterol and salbutamol], followed by corticosteroids, long acting beta-agonists [salmeterol and formoterol] and sodium cromoglycate).
Makino S, Adachi M, Ohta K, Kihara N, Nakajima S, Nishima S, Fukuda T, et al., Safety of Sustained-Release Theophylline and Injectable Methylxanthines Committee. (2006). Asthma Prevention and Management Guidelines Committee. A prospective survey on safety of sustained-release theophylline in treatment of asthma and COPD. Allergol Int. (Survey of 66 medical centers for reports of safety of theophylline in 3921 patients with asthma identified 54 adverse reactions [1.4%], including one instance of ALT elevation, not otherwise described).
van der Wouden JC, Uijen JH, Bernsen RM, Tasche MJ, de Jongste JC, Ducharme F. (2008). Inhaled sodium cromoglycate for asthma in children. Cochrane Database Syst Rev. (Systematic review of literature on safety and efficacy of sodium cromoglycate for asthma concludes that it is safe, but has little evidence for efficacy; no mention of hepatotoxicity).
Expert Panel Report 3 (EPR3): Guidelines for the Diagnosis and Management of Asthma. NIH Publication 08-4051. Available at: http://www.nhlbi.nih.gov/guidelines/asthma/asthgdln.htm (National Heart, Lung, and Blood Institute supported expert panel committee’s guidelines to the treatment of asthma which are regularly updated and available online).
(2013). Drugs for asthma and COPD. Treat Guidel Med Lett. (Concise review of current recommendations for medical therapy of asthma mentions that both montelukast and zafirlukast have been reported to cause life-threatening hepatic injury and that liver tests should be monitored).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, the only antiasthma drug implicated was montelukast [4 cases: 0.5%]).
(2016). Mepolizumab (Nucala) for severe eosinophilic asthma. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of mepolizumab shortly after its approval in the US for eosinophilic asthma; mentions side effects of headache, back pain, fatigue and infusion site reactions, but does not mention ALT elevations or hepatotoxicity).
(2016). Reslizumab (Cinqair) for severe eosinophilic asthma. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of reslizumab shortly after its approval in the US; mentions side effects of oropharyngeal pain, CK elevations and myalgia and serious adverse events of anaphylaxis [0.3%] and malignancy, but does not mention ALT elevations or hepatotoxicity).
(2017). Drugs for asthma. Med Lett Drugs Ther. (Concise review of medications used for asthma including the leukotriene modifiers; mentions that zileuton and zafirlukast have been reported to cause life-threatening hepatic injury and that monitoring of liver tests during therapy is recommended).
(2018). Benralizumab (Fasenra) for severe eosinophilic asthma. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of benralizumab shortly after its approval as therapy of eosinophilic asthma in the US; mentions adverse event rates were similar with benralizumab as placebo and does not mention ALT elevations or hepatotoxicity).
(2019). Dupilumab (Dupixent) for asthma. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of dupilumab [monoclonal antibody to the IL4 receptor alpha subunit] shortly after its approval in the US; mentions side effects of injection site reactions, transient eosinophilia, conjunctivitis and anaphylaxis, but does not mention ALT elevations or hepatotoxicity).
(2020). Drugs for asthma. Med Lett Drugs Ther. (Concise review of medications used for asthma including monoclonal antibodies to IgE, IL5, and the IL5 and IL4 receptors, which are used largely for eosinophilic asthma that has not responded adequately to conventional medications; mentions that zileuton and zafirlukast have been reported to cause life-threatening hepatic injury and that monitoring of liver tests during therapy is recommended, whereas discussions of the other anti-asthma medications do not mention ALT elevations or hepatotoxicity).